# Dronedarone

## OVERVIEW

### Introduction

Dronedarone is an antiarrhythmic and a synthetic derivative of amiodarone that is used for maintaining sinus rhythm for patients with atrial fibrillation or flutter. Dronedarone is associated with a variable rate of serum enzyme elevations during therapy and to rare instances of clinically apparent liver injury, which can be severe and have resulted in deaths and need for liver transplantation.

### Background

Dronedarone (droe ne’ da rone) is a synthetic derivative of amiodarone, a benzofuran derivative that is a structural analogue of thyroid hormone. However, unlike amiodarone and thyroxine, dronedarone is not iodinated and was specifically designed to avoid some of the end-organ adverse effects associated with amiodarone use. Dronedarone, like amiodarone, has a multitude of electrophysiologic properties, including inhibition of several potassium currents as well as sodium and slow L-type calcium channels. In clinical trials, dronedarone improved maintenance of sinus rhythm in patients with atrial fibrillation or flutter. Dronedarone was approved for use in the United States in 2009 and its current indications are for oral treatment of paroxysmal or persistent atrial fibrillation or flutter. Dronedarone is available in tablets of 400 mg under the brand name Multaq and the recommended maintenance dose in adults in 400 mg twice daily (an initial loading dose of twice that amount if usually recommended). Dronedarone appears to be less effective than amiodarone, but is better tolerated. Side effects of dronedarone include gastrointestinal upset, nausea, diarrhea, headache and mild elevations in serum creatinine. Recent large, long term trials of dronedarone have suggested that its use is associated with an increased risk in cardiovascular events, heart failure, strokes and deaths in certain populations.

### Hepatotoxicity

Chronic therapy with dronedarone has been associated with mild serum enzyme elevations in up to 12% of patients, but similar rates were found in comparator arms and even in placebo recipients. The serum aminotransferase elevations that occur during chronic dronedarone therapy are generally mild-to-moderate in severity and asymptomatic, rarely requiring discontinuation or dose modification. In preapproval clinical trials, clinically apparent liver injury was not described. Since its approval and more wide scale use, however, dronedarone has been linked to several cases of clinically apparent liver injury with jaundice, some of which have been severe and some fatal. The onset of injury ranged from 2 to 11 months and the clinical presentation was similar to acute viral hepatitis, with symptoms of fatigue and abdominal discomfort followed by jaundice and a hepatocellular pattern of serum enzyme elevations. Several instances have resulted in acute liver failure requiring emergency liver transplantation. The liver injury associated with dronedarone is distinctly different from that related to amiodarone. The injury is typically hepatocellular rather than cholestatic or mixed. The latency to onset of amiodarone associated liver injury can be quite long, several years and rarely shorter than 6 months. In contrast, dronedarone liver injury typically arises within 2 to 6 months. Therapy with amiodarone has been associated with cirrhosis and histologic findings resembling alcoholic liver disease. Dronedarone has not been implicated in causing cirrhosis, and the injury is more typical of moderate to severe idiosyncratic, hepatocellular drug induced liver injury.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of dronedarone hepatotoxicity is not clear. Dronedarone is extensively metabolized by the cytochrome P450 system (predominantly CYP 3A) and the liver injury may be due to a toxic or immunogenic metabolite. Dronedarone is also associated with drug-drug interactions and should not be used with inducers or inhibitors of CYP 3A4.

### Outcome and Management

The liver injury attributed to dronedarone can be severe and lead to liver failure and death. There are no known specific therapies for reversing dronedarone effects. There is also no information about cross sensitivity with hepatic injury from amiodarone, but other approaches to atrial arrhythmia control are probably advisable.

Drug Class: Antiarrhythmic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dronedarone – Multaq®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dronedarone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dronedarone | 141626-36-0 | C31-H44-N2-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2026

Abbreviations: iv, intravenous; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 648-52. (Expert review of hepatotoxicity published in 1999; patterns of liver injury associated with amiodarone include frequent minor serum enzyme elevations [14-83%] and, less commonly, chronic liver disease resembling alcoholic hepatitis and cirrhosis, acute hepatitis with jaundice, phospholipidosis, Reye syndrome and cholestasis; dronedarone is not discussed).
De Marzio DH, Navarro VJ. Antiarrhythmics. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 520-22. (Review of hepatotoxicity of cardiovascular drugs mentions that two cases of acute liver failure attributed to dronedarone that were reported after its approval in 2009, which led to an FDA warning and recommendation for routine periodic monitoring of liver tests, the effectiveness of which has not been shown).
Knollman BC, Roden DM. Antiarrhythmic drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's The pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 547-572. (Textbook of pharmacology and therapeutics).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to amiodarone, but none to dronedarone, which however was not approved in the United States until 2009). 18955056
Singh BN, Connolly SJ, Crijns HJ, Roy D, Kowey PR, Capucci A, Radzik D, et al; EURIDIS and ADONIS Investigators. Dronedarone for maintenance of sinus rhythm in atrial fibrillation or flutter. N Engl J Med 2007; 357: 987-99. (Prospective study of dronedarone, a benzofuran derivative of amiodarone, versus placebo in 828 patients with atrial fibrillation or flutter for up to one year: abnormalities in liver tests occurred in 12.2% of dronedarone vs 13.6% of placebo recipients; no mention of clinically apparent liver injury). 17804843
Davy JM, Herold M, Hoglund C, Timmermans A, Alings A, Radzik D, Van Kempen L; ERATO Study Investigators. Dronedarone for the control of ventricular rate in permanent atrial fibrillation: the Efficacy and safety of dronedarone for the control of ventricular rate during atrial fibrillation (ERATO) study. Am Heart J 2008; 156: 527. (Controlled trial of dronedarone vs placebo for 6 months in 174 patients with permanent atrial fibrillation; no specific mention of ALT elevations or hepatotoxicity but authors conclude: "dronedarone was well tolerated with no evidence of organ toxicities"). 18760136
Køber L, Torp-Pedersen C, McMurray JJ, Gøtzsche O, Lévy S, Crijns H, Amlie J, et al; Dronedarone Study Group. Increased mortality after dronedarone therapy for severe heart failure. N Engl J Med 2008; 358: 2678-87. (Controlled trial of dronedarone vs placebo in 627 patients with symptomatic heart failure was terminated early because of excess mortality in dronedarone [8.1%] compared to placebo treated subjects [3.8%], largely due to worsening of heart failure; no mention of hepatotoxicity). 18565860
Dronedarone (Multaq) for atrial fibrillation. Med Lett Drugs Ther 2009; 51 (1322): 78-80. (Concise review of the mechanism of action, clinical efficacy and safety of dronedarone shortly after its approval in the United States). 19798011
Patel C, Yan GX, Kowey PR. Dronedarone. Circulation 2009; 120: 636-44. (Review of the chemical structure, mechanism of action, pharmacokinetics, clinical efficacy and safety of dronedarone; in the 4640-patient ATHENA trial, liver test abnormalities occurred no more frequently in dronedarone than in placebo treated subjects [0.5% vs 0.6%]). 19687370
Le Heuzey JY, De Ferrari GM, Radzik D, Santini M, Zhu J, Davy JM. A short-term, randomized, double-blind, parallel-group study to evaluate the efficacy and safety of dronedarone versus amiodarone in patients with persistent atrial fibrillation: the DIONYSOS study. J Cardiovasc Electrophysiol 2010; 21: 597-605. (Controlled trial of dronedarone vs amiodarone in 504 patients with persistent atrial fibrillation found higher rate of recurrence with dronedarone, whereas thyroid, neurologic, skin and ocular adverse events were less; ALT or AST elevations [2 times ULN] occurred at similar rates [12% vs 10.6%]). 20384650
Christiansen CB, Torp-Pedersen C, Køber L. Efficacy and safety of dronedarone: a review of randomized trials. Expert Opin Drug Saf 2010; 9: 189-99. (Review of efficacy and safety of dronedarone based on results of 7 controlled trials; no mention of ALT elevations or hepatotoxicity). 20001756
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to amiodarone, dronedarone or other antiarrhythmic agents). 20949552
Connolly SJ, Camm AJ, Halperin JL, Joyner C, Alings M, Amerena J, Atar D, et al; PALLAS Investigators. Dronedarone in high-risk permanent atrial fibrillation. N Engl J Med 2011; 365: 2268-76. (Among 3236 elderly adults with persistent atrial fibrillation treated with dronedarone or placebo, there was an increased rate of primary outcomes including death in the dronedarone treated group, and the study was terminated early; ALT elevations above 3 times ULN occurred in 1.5% on dronedarone versus 0.6% on placebo). 22082198
In brief: FDA warning on dronedarone (Multaq). Med Lett Drugs Ther 2011; 53 (1359): 17. (Warning from FDA of several cases of severe liver injury and liver failure, two requiring transplantation after 4.5 and 6 months of dronedarone therapy). 21383666
Safety of dronedarone (Multaq). Med Lett Drugs Ther 2011; 53 (1379-1380): 103-4. (Discussion of safety of dronedarone mentioning studies showing that it is associated with an increased risk of stroke, heart failure, and cardiovascular death). 22173456
Joghetaei N, Weirich G, Huber W, Büchler P, Estner H. Acute liver failure associated with dronedarone. Circ Arrhythm Electrophysiol 2011; 4: 592-3. (70 year old woman developed jaundice 6 months after starting dronedarone for atrial fibrillation [peak bilirubin 30.3 mg/dL, ALT and Alk P not provided], with progressive hepatic failure leading to emergency liver transplantation 20 days after presentation). 21846890
Del Pozo Ruiz JJ, Martín Sanz A, Alvarez Vicente G, Arenas Monzo C. [Dronedarone-associated hepatotoxicity. A propos of a case]. Farm Hosp 2012; 36: 545-7. Spanish. PMID: 23461450 (75 year old man developed abdominal pain, nausea and liver test abnormalities a week after starting dronedarone [bilirubin 1.9 mg/dL, ALT 478 U/L, Alk P normal], symptoms resolving rapidly and all values falling into the normal range within 3 weeks of stopping).
De Ferrari GM, Dusi V. Drug safety evaluation of dronedarone in atrial fibrillation. Expert Opin Drug Saf 2012; 11: 1023-45. (Extensive review of structure, mechanism of action, pharmacokinetics, clinical efficacy, and safety of dronedarone in comparison to amiodarone). 22971242
Jahn S, Zollner G, Lackner C, Stauber RE. Severe toxic hepatitis associated with dronedarone. Curr Drug Saf 2013; 8: 201-2. (69 year old woman developed jaundice 11 months after starting dronedarone and 4 months after starting phenprocoumon [bilirubin 4.9 rising to 33.5 mg/dL, ALT 1314 U/L, Alk P 244 U/L, ANA 1:160, peak INR 1.4], subsequently worsening, but ultimately recovering fully within 6 months of onset). 23789833
Friberg L. Safety of dronedarone in routine clinical care. J Am Coll Cardiol 2014; 63: 2376-84. (Among 174,995 patients with atrial fibrillation in a Swedish health registry, there was a lower rate of mortality among the 4856 who received dronedarone [1.3% annually] than among those who did not [14%] and no excess in clinically apparent liver disease [0.2% vs 0.6% annually]). 24727250
Hohnloser SH. Dronedarone: "Real-world" data vis-à-vis data from randomized clinical trials. J Am Coll Cardiol 2014; 63: 2385-7. (Editorial in response to analysis of a Swedish registry by Friberg [2014]). 24727252
Gao S, Dai W, Zhang L, Juhaeri J, Wang Y, Caubel P. Risk of cardiovascular events, stroke, congestive heart failure, interstitial lung disease, and acute liver injury: dronedarone versus amiodarone and other antiarrhythmics. J Atr Fibrillation 2013; 6: 890. (Analysis of health care database of 10,455 adults with atrial fibrillation or flutter seen between 2009 and 2010 for serious outcomes including myocardial infarction, stroke, congestive heart failure, interstitial lung disease and acute liver injury found no excess of instances of acute liver injury among 1727 who were started on dronedarone therapy). 28496906
Arif SA, Drury R, Ader P. Impact of Food and Drug Administration hepatotoxicity warning on prescribing and monitoring of dronedarone in a tertiary teaching hospital. Int J Pharm Pract 2015; 23: 456-60. (Retrospective analysis of frequency of prescriptions for dronedarone for the year before and year after the FDA issued a warning letter concerning liver injury at a single medical referral center showed a 50% decrease in number of prescriptions, but no increase in rate of ALT monitoring of recipients). 26382915
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases were attributed to amiodarone and 2 to dronedarone). 25754159
Gao S, Dai W, Zhang L, Juhaeri J, Wang Y, Caubel P. Risk of cardiovascular events, stroke, congestive heart failure, interstitial lung disease, and acute liver injury: dronedarone versus amiodarone and other antiarrhythmics. J Atr Fibrillation. 2013;6:890. (Analysis of a health database on 10,455 adults with atrial fibrillation or flutter treated with one of five antiarrhthmics, dronedarone [n=1,727, followed for 6 months or more] was not associated with an increased risk of cardiovascular events, stroke, heart failure, interstitial lung disease, or acute liver injury [5 cases, none hospitalized]). 28496906
Felser A, Stoller A, Morand R, Schnell D, Donzelli M, Terracciano L, Bouitbir J, et al. Hepatic toxicity of dronedarone in mice: role of mitochondrial β-oxidation. Toxicology. 2014;323:1-9. (Studies in mice showed that dronedarone [400 mg/kg/day for 1 week] led to weight loss and increases in serum ALT and bilirubin levels and impaired oxidation in mitochondria). 24881592
Guzmán Ramos MI, Romero García T, Márquez Saavedra E, Suárez García E, Martínez Castillo R. Dronedarone-induced liver injury. A case report. Gastroenterol Hepatol. 2018;41:636-638. (78 year old woman with heart disease and atrial fibrillation developed fatigue and jaundice 6 months after starting dronedarone [bilirubin 13.6 mg/dL, ALT 453 U/L, Alk P not provided] with progressive hepatic encephalopathy, ascites, and death 18 days later). 29452933
Grimaldi-Bensouda L, Wedemeyer H, Wiegand J, Lohse AW, Benichou J, Rossignol M, Larrey D, et al; PGRx-ALI study group. Dronedarone, amiodarone and other antiarrhythmic drugs, and acute liver injuries: a case-referent study. Int J Cardiol. 2018;266:100-105. (Comparison of 252 cases of suspected drug-induced liver injury collected by a network of 59 centers in Germany between 2010 and 2014 vs 1081 age and sex matched concurrent controls, showed that dronedarone was used by 1.2% [3 cases] vs 0.4% and amiodarone by 2.4% [6 cases] vs 0.6%, the “adjusted” odds ratio being slightly higher for amiodarone). 29887424
Dilaveris P, Tousoulis D. Do not condemn solely dronedarone for acute liver injury: It's a class effect. Int J Cardiol. 2018;266:149-150. (Editorial in response to Grimaldi-Bensouda [2018] argues that while both dronedarone and amiodarone can cause liver injury, it is a class effect and dronedarone may be better tolerated than amiodarone). 29887433
Siddique AS, Siddique O, Einstein M, Urtasun-Sotil E, Ligato S. Drug and herbal/dietary supplements-induced liver injury: A tertiary care center experience. World J Hepatol. 2020;12:207-219. (Among 38 cases of suspected drug induced liver injury that underwent liver biopsy seen at a single referral center in China between 2012 and 2018, one was attributed to dronedarone [bilirubin 3.3 mg/dL, ALT 93 U/L, Alk P 477 U/L], histology showing a mixed-cholestatic hepatitis with steatosis and bile duct injury). 32547688
Khan ZH, Mukhtar K, Ahmed MM, Zaidi SR, Abd Algayoum R. Dronedarone-mediated acute hepatic and renal toxicity. Cureus. 2020;12:e9611. (86 year old man with rapid atrial fibrillation despite long term amiodarone therapy was given 3 doses of dronedarone [amount not provided] without change in rapid heart rate leading to cardioversion 24 hours after which serum ALT was 3151 U/L, AST 3930 U/L, Alk P 144 U/L, INR 6.1, and creatinine 5.4 mg/dL, which then fell towards normal with no further therapy). 32923213
Pop A, Halegoua-DeMarzio D, Barnhart H, Kleiner D, Avigan M, Gu J, Chalasani N, et al. Amiodarone and dronedarone causes liver injury with distinctly different clinical presentations. Dig Dis Sci. 2024;69:1479-1487. (In a U.S. prospective study of drug-induced liver injury conducted between 2004 and 2016, 3 cases of dronedarone vs 10 cases of amiodarone were identified and compared; dronedarone cases were on average younger [median age 58 vs 70 years], with a latency of 2 to 6 months vs longer, a hepatocellular pattern of injury vs mixed or cholestatic, and hepatitis-like histologic findings vs steatohepatitis with Mallory bodies and fibrosis or cirrhosis). 38416280
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, no mention of dronedarone, but the estimated rate of injury from amiodarone was 1:2,500 persons per year). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database between 2012 and 2022, none were attributed to amiodarone or dronedarone). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916 (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study between 2005 and 2019 included 8 cases [0.6%] attributed to amiodarone, occurring at an estimated rate of 1 per 4100 persons treated [95% confidence intervals 1:1,200 to 1:6,800], while there were too few cases [less than 5] attributed to dronedarone and lack of information on number treated making it impossible to estimate a rate of liver injury from its use).
Pundi K, Fan J, Kabadi S, Din N, Blomström-Lundqvist C, Camm AJ, Kowey P, et al. Dronedarone versus sotalol in antiarrhythmic drug-naive veterans with atrial fibrillation. Circ Arrhythm Electrophysiol. 2023;16:456-467. (Analysis of a matched cohort of 3106 patients from the VA Health Administration files who were treated with dronedarone vs a similar number with sotalol for atrial fibrillation after 2012 with uncertain amount of follow up[~1 year] showing no difference in hospitalization for cardiovascular disease or all cause mortality). 37485722

## OTHER REFERENCE LINKS

1. Recent References on Dronedarone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dronedarone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Dronedarone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dronedarone)